# Pomalidomide

## OVERVIEW

### Introduction

Pomalidomide is an immunomodulatory and antineoplastic agent that is used in the therapy of multiple myeloma. Pomalidomide, like the structurally related agents thalidomide and lenalidomide, is associated with a low rate of serum aminotransferase elevations during therapy and has been implicated in causing rare instances of clinically apparent liver injury which can be severe.

### Background

Pomalidomide (pom" a lid' oh mide) is a thalidomide derivative (3-amino-thalidomide) similar to lenalidomide that has potent immunomodulatory and antiangiogenic activity and is used as an antineoplastic agent. The mechanism of action of these agents in the treatment of multiple myeloma is not well defined but may relate to inhibition of tumor necrosis factor (TNF) alpha, a potent proinflammatory cytokine or to stimulation of T and NK cell activity. In vitro and in animal models, pomalidomide had greater antineoplastic activity and was less toxic than thalidomide and lenalidomide, but direct comparisons of these agents in humans have not been done. Pomalidomide was approved for use (combined with dexamethasone) in the United States for refractory multiple myeloma in 2015. It subsequently was given accelerated approval as therapy of Kaposi sarcoma. Pomalidomide has also been used on an experimental basis for myelofibrosis and other myeloproliferative disorders. Pomalidomide is available in capsules of 1, 2, 3 and 4 mg under the brand name Pomalyst. The recommended dose for multiple myeloma is 4 mg daily for 21 days in cycles of 28 days indefinitely or until there is disease progression or intolerance. The dose in Kaposi sarcoma is 5 mg daily for 21 days in cycles of 28 days. Its use is restricted because of teratogenicity and strict adherence to birth control (for both men and women) is required. Side effects of pomalidomide are common and similar to those of thalidomide and lenalidomide and include sedation, dizziness, orthostatic hypotension, neutropenia, thrombocytopenia, anemia, peripheral neuropathy and arterial and venous thromboembolism (for which reason it is usually given with antiplatelet agents such as aspirin or with anticoagulation). Rare but potentially severe adverse events include severe cutaneous reactions, severe neuropathy, secondary malignancies, tumor lysis syndrome and hypersensitivity reactions. Pomalidomide is a teratogen and possible cause of severe birth defects and is available only as a part of a strict Risk Evaluation and Mitigation Strategy (REMS), which requires physician training, written patient informed consent, strict birth control measures, regular monitoring and reporting.

### Hepatotoxicity

Serum enzyme elevations occur in 1% to 2% of patients taking pomalidomide and are more frequent with higher doses. The enzyme abnormalities are usually mild and self-limited and rarely require drug discontinuation. In addition pomalidomide has been implicated in rare instances of clinically apparent, acute liver injury which can be severe and has been reported to lead to deaths from acute liver failure. However, few of these cases have been published and the clinical features, course and outcome of the typical case of liver injury from pomalidomide have not been defined. Both thalidomide and lenalidomide have been implicated in cases of clinically apparent acute liver injury and the presentation and course of injury is likely to be similar to that caused by pomalidomide. The latency to onset of cases of thalidomide associated liver injury is usually within 1 to 6 weeks of starting the antineoplastic agent. The clinical features vary greatly and can be hepatocellular or cholestatic. Cases of acute liver failure as well as vanishing bile duct syndrome with rapid marked cholestasis and hepatic failure have been described with thalidomide and lenalidomide. Immunoallergic features may be prominent and instances of Stevens Johnson syndrome and toxic epidermal necrolysis with and without liver injury have also been linked to therapy with thalidomide and its derivatives. In most cases, the injury resolves rapidly after therapy is stopped. Monitoring of liver tests at monthly intervals is recommended when using thalidomide and its derivatives, and stopping therapy early may play an important role in preventing severe and fatal outcomes.

Pomalidomide and the thalidomide derivatives have also been implicated in causing an increased risk of graft-vs-host disease after autologous or allogeneic hematopoietic stem cell transplantation (HSCT) as well as after liver, kidney and heart transplantation. There appears to be cross reactivity to this complication among lenalidomide, pomalidomide and thalidomide. Therapy usually requires discontinuation of the antineoplastic agent as well as treatment with high doses of corticosteroids and tacrolimus or sirolimus. Furthermore, hepatic graft-vs-host disease can occasionally present with an acute hepatitis that resembles hepatocellular drug induced liver injury.

Reactivation of hepatitis B has been reported in patients receiving thalidomide, lenalidomide and pomalidomide, but generally only after HSCT and the role of these agents in causing reactivation is not always clear. Indeed, in studies of large numbers of patients treated for multiple myeloma the major risk factor for hepatitis B reactivation was found to be HSCT rather than the specific antineoplastic drugs being used. Indeed, lenalidomide therapy is associated with a reduced risk of reactivation in patients with HSCT (although dexamethasone, thalidomide and bortezomib were not), perhaps because of the immune enhancement typically caused by lenalidomide.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of pomalidomide hepatotoxicity is not clear, but it may be related to its activity in reducing TNF-α production, a potent inflammatory cytokine that activates T cells and promotes inflammation, but is also necessary for normal liver regeneration. Alternatively, the injury may be triggered by an intermediate of its metabolism, which is largely mediated by hepatic microsomal enzymes, CYP 1A2 and 3A4.

### Outcome and Management

The severity of pomalidomide induced liver injury ranges from transient, asymptomatic elevations in serum enzymes to acute liver injury with jaundice to severe acute liver failure and death. Vanishing bile duct syndrome has been reported with use of thalidomide and lenalidomide but not specifically with pomalidomide. Regular monitoring of liver tests is recommended during pomalidomide therapy. Patients who develop liver test abnormalities should stop therapy and restart treatment only if the abnormalities are transient and not associated with symptoms or jaundice. While not proven, the various thalidomide derivatives are likely to demonstrate cross sensitivity to clinically apparent liver injury.

Drug Class: Antineoplastic Agents, Miscellaneous

Other Related Drugs: Lenalidomide, Thalidomide

## CASE REPORT

### Case 1. Acute liver injury with jaundice due to pomalidomide.(1)

A 47 year old African American man with refractory multiple myeloma, who had received multiple courses of therapy and an allogenic hematopoietic cell transplant, developed nausea and rash 3 weeks into a first course of pomalidomide (2 mg daily for 21 days) and dexamethasone (20 mg weekly). Shortly thereafter he was found to be jaundiced and was admitted for evaluation and management. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. He had had several bouts of graft-vs-host disease after the hematopoietic cell transplant which had been managed with immunosuppression and extracorporeal photopheresis. On hospital admission, total bilirubin was 16.2 mg/dL (direct 12 mg/dL), ALT 1241 U/L, AST 552 U/L, alkaline phosphatase (Alk P) 337 U/L. The prothrombin time was 22.8 seconds. Tests for hepatitis A, B and C and for EBV and CMV infection were negative. A CT of the abdomen showed no evidence of biliary obstruction. A liver biopsy showed severe hepatocyte necrosis and portal inflammation with lymphocytes, plasma cells and eosinophils. The bile ducts showed reactive changes but no inflammation or loss, and hepatic arteries and veins were normal without endothelitis. The biopsy was considered compatible with severe drug induced liver injury and not suggestive of acute or chronic graft-vs-host disease. Over the next few weeks, liver tests improved and liver tests were only mildly abnormal when he was seen as an outpatient two weeks later.

#### Key Points

Medication: | Pomalidomide (2 mg daily)
Pattern: | Hepatocellular (R ratio=12.4)
Severity: | 4+ (jaundice, hospitalization, coagulopathy)
Latency: | 3 weeks
Recovery: | Marked improvement within 2 weeks
Other medications: | None mentioned, except for dexamethasone.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
3 weeks | 0 | Symptoms of increasing nausea and rash
4 weeks | ~6 days | 1241 | 337 | 16.2 | Admission
| 8 days | 900 | 280 | 14.0
| 9 days | 820 | 340 | 18.4
| 10 days | 640 | 400 | 17.4
5 weeks | 11 days | 560 | 380 | 14.2 | Discharge
6 weeks | 19 days | 80 | 200 | 4.4
Normal Values** | | <40 | <135 | <1.2

* Most values estimated from Figure 1.

** Normal values not provided, these being standard levels

#### Comment

This man with advanced refractory multiple myeloma, who had received autologous followed by an allogenic hematopoietic cell transplants, developed jaundice approximately 3 weeks after starting a new chemotherapy regimen of pomalidomide and dexamethasone. The jaundice was initially thought to be due to graft-vs-host disease, but a liver biopsy was more compatible with a severe, acute drug induced hepatocellular injury. Other causes of acute liver injury were appropriately excluded. The time to onset, pattern of serum enzyme elevations, history of preexisting liver disease (graft-vs-host liver injury) and rapid improvement with stopping the implicated agent all resemble the features of drug induced liver injury from thalidomide and lenalidomide. It is not known whether there is cross sensitivity to liver injury among the different thalidomide derivatives. Interestingly, he had previously received thalidomide, evidently without liver injury, so that this episode might represent a reexposure.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pomalidomide – Pomalyst®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pomalidomide)

Product labeling at DailyMed, National Library of Medicine, NIH

CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Thalidomide | 50-35-1 | C13-H10-N2-O4 | SID: 134971183
Lenalidomide | 191732-72-6 | C13-H13-N3-O3 | SID: 135134887
Pomalidomide | 19171-19-8 | C13-H11-N3-O4 | SID: 135089995

## CITED REFERENCES

1 Pauff JM, Gonzalez RS, Sajnani KP, Kassim A, Jagasia M. (2014). Post-allograft pomalidomide and reversible hepatotoxicity. Bone Marrow Transplant.

## ANNOTATED BIBLIOGRAPHY

References updated: 30 August 2022

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999; thalidomide and pomalidomide are not discussed).
Davern TJ. Hepatotoxicity of immunomodulating agents and the transplant situation. Thalidomide. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, p. 675. (Mentions that thalidomide rarely causes liver injury, but case reports of hepatocellular injury with variable degrees of jaundice have been described, largely in patients with preexisting chronic liver disease).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Thalidomide and Lenalidomide. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1225-27. (Textbook of pharmacology and therapeutics).
Clark TE, Edom N, Larson J, Lindsey LJ. (2001). Thalomid (Thalidomide) capsules: a review of the first 18 months of spontaneous postmarketing adverse event surveillance, including off-label prescribing. Drug Saf. (During first 18 months of postmarketing use of thalidomide in 10,456 patients, 1210 adverse event reports were received, including 4 cases of hepatic failure arising after 1-4 weeks of treatment, although 3 were considered unrelated to therapy).
Fowler R, Imrie K. (2001). Thalidomide-associated hepatitis: a case report. Am J Hematol. (Patient with chronic hepatitis C and advanced plasma cell leukemia developed jaundice and nausea 1 week after starting thalidomide [bilirubin 0.4 initially rising to 9.3 mg/dL, ALT 91 to 829 U/L, Alk P 100 to 120 U/L], resolving rapidly upon stopping; high HCV RNA levels noted).
Trojan A, Chasse E, Gay B, Pichert G, Taverna C. (2003). Severe hepatic toxicity due to thalidomide in relapsed multiple myeloma. Ann Oncol. (62 year old woman with multiple myeloma developed acute liver failure after 7 months of thalidomide therapy [bilirubin not given, ALT ~2000 U/L, LDH ~6000 U/L], enzymes falling to normal in 1 week; overall, suggestive of ischemic hepatitis rather than drug induced liver injury).
Teo SK. (2005). Properties of thalidomide and its analogues: implications for anticancer therapy. AAPS J. (Review of the properties and experimental uses of thalidomide as an inhibitor of TNF-α and other cytokines in multiple myeloma and several solid tumors).
Hanje AJ, Shamp JL, Thomas FB, Meis GM. (2006). Thalidomide-induced severe hepatotoxicity. Pharmacotherapy. (Elderly woman with multiple myeloma developed jaundice and marked ALT elevations 6 weeks after starting thalidomide [ALT 2205 U/L; bilirubin 5.6 mg/dL], resolving within 3 months of stopping: Case 1 for Thalidomide).
Hamadani M, Benson DM, Copelan EA. (2007). Thalidomide-induced fulminant hepatic failure. Mayo Clin Proc. (64 year old woman with multiple myeloma and HBsAg in serum developed acute liver failure 12 days after starting thalidomide [bilirubin 16.7 mg/dL, ALT 410 U/L, Alk P 101 U/L, no change in HBV DNA], some improvement on stopping drug, but had worsening coagulopathy and renal failure and died 14 days later).
Melchert M, List A. (2007). The thalidomide saga. Int J Biochem Cell Biol. (Review of history of thalidomide and current understanding of its actions as an anticytokine; no mention of side effects).
Hussain S, Browne R, Chen J, Parekh S. (2007). Lenalidomide-induced severe hepatotoxicity. Blood. (57 year old man with multiple myeloma developed jaundice 1 week after starting lenalidomide, a derivative of thalidomide [bilirubin 7.2 mg/dL, ALT 90 U/L, Alk P 210 U/L], resolving within 3 weeks).
Dabak V, Kuriakose P. (2009). Thalidomide-induced severe hepatotoxicity. Cancer Chemother Pharmacol. (2 women with multiple myeloma; 79 year old developed jaundice 7 weeks after starting thalidomide [bilirubin 27.9 mg/dL, ALT 392 U/L, Alk P 1172 U/L], with persistent jaundice, bile duct loss on liver biopsy and death 4 months later; 57 year old developed raised enzymes one month after starting thalidomide [bilirubin not given, ALT 398 U/L, Alk P 175 U/L], resolving within 2 weeks of stopping).
Levesque E, Bradette M. (2009). Hepatotoxicity as a rare but serious side effect of thalidomide. Ann Hematol. (36 year old woman with multiple myeloma developed liver test abnormalities 5 weeks after starting thalidomide [bilirubin normal, peak ALT ~1300 U/L], resolving within 20 days of stopping).
Jain P. (2009). Lenalidomide-induced acute liver failure. Blood Transfus. (93 year old man with myelodysplastic syndrome and HBsAg in serum developed jaundice 10 days after starting lenalidomide [bilirubin 9.2 mg/dL, ALT 2670 U/L, Alk P 342 U/L, IgM anti-HBc positive, but HBV DNA negative], resolving over following 4 weeks; patient later tolerated restarting lenalidomide in combination with adefovir).
Castaneda CP, Brandenburg NA, Bwire R, Burton GH, Zeldis JB. (2009). Erythema multiforme/Stevens-Johnson syndrome/toxic epidermal necrolysis in lenalidomide-treated patients. J Clin Oncol. (After approximately 57,000 patients had received lenalidomide, the sponsor received 12 reports of Stevens-Johnson Syndrome, 3 of erythema multiforme and 1 of toxic epidermal necrolysis, arising 3-112 days after starting; often sparse data were available and there was no mention of liver injury or jaundice).
Tefferi A, Verstovsek S, Barosi G, Passamonti F, Roboz GJ, Gisslinger H, Paquette RL, et al. (2009). Pomalidomide is active in the treatment of anemia associated with myelofibrosis. J Clin Oncol. (Among 84 patients with anemia due to myelofibrosis who were treated with pomalidomide [0.5 or 2 mg daily] with or without prednisone or prednisone alone, side effects were largely due to myelosuppression and venous thromboses [5%]; no mention of ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to thalidomide or its derivatives).
Begna KH, Mesa RA, Pardanani A, Hogan WJ, Litzow MR, McClure RF, Tefferi A. (2011). A phase-2 trial of low-dose pomalidomide in myelofibrosis. Leukemia. (Among 58 patients with myelofibrosis treated with low doses of pomalidomide [0.5 mg daily], anemia responses occurred in 10 subjects [16%]; side effects were said to be less than with standard doses; no mention of ALT elevations or hepatotoxicity).
Zanella MC, Rubbia-Brandt L, Giostra E, Chalandon Y, Hadengue A, Spahr L. (2011). A case of drug-induced hepatitis due to lenalidomide. Case Rep Gastroenterol. (50 year old man developed severe skin rash 3 months after starting lenalidomide that resolved upon stopping, but developed serum enzyme elevations one week after restarting lenalidomide 2 years later [bilirubin normal, ALT 509 U/L, Alk P 198 U/L], resolving upon stopping).
Vilas-Boas F, Gonçalves R, Sobrinho Simões M, Lopes J, Macedo G. (2012). Thalidomide-induced acute cholestatic hepatitis: case report and review of the literature. Gastroenterol Hepatol. (77 year old man with multiple myeloma developed jaundice 4 weeks after starting chemotherapy with melphalan, prednisone and thalidomide [bilirubin 11.4 mg/dL, ALT 333 U/L, Alk P 4 times ULN], worsening for a week after stopping thalidomide and then improving; patient later tolerated melphalan but died of pneumonia shortly thereafter).
Nojkov B, Signori C, Konda A, Fontana RJ. (2012). Lenalidomide-associated hepatotoxicity--a case report and literature review. Anticancer Res. (67 year old man with multiple myeloma developed fatigue within 1 week of starting a 2nd 3-week course of lenalidomide [bilirubin 4.4 mg/dL, ALT 139 U/L, Alk P 190 U/L], with rapid resolution upon stopping [within 8 days]).
Richardson PG, Siegel D, Baz R, Kelley SL, Munshi NC, Laubach J, Sullivan D, et al. (2013). Phase 1 study of pomalidomide MTD, safety, and efficacy in patients with refractory multiple myeloma who have received lenalidomide and bortezomib. Blood. (Among 38 patients with refractory multiple myeloma treated with pomalidomide [2-5 mg daily for 21 days in 28 day cycles], dose limiting toxicities were uncommon; no mention of ALT elevations or hepatotoxicity).
Leleu X, Attal M, Arnulf B, Moreau P, Traulle C, Marit G, Mathiot C, et al. (2013). Pomalidomide plus low-dose dexamethasone is active and well tolerated in bortezomib and lenalidomide-refractory multiple myeloma: Intergroupe Francophone du Myélome 2009-02. Blood. (Among 84 patients with refractory multiple myeloma treated with pomalidomide in 28 day courses, the 1 year relapse-free survival rate was 44%; all patients had adverse events which were usually hematologic; no mention of ALT elevations or hepatotoxicity).
Lacy MQ, McCurdy AR. (2013). Pomalidomide. Blood. (Review of safety and efficacy of pomalidomide which the authors claim has a lower rate of hematologic toxicities than thalidomide and lenalidomide; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to thalidomide or its derivatives).
Richardson PG, Siegel DS, Vij R, Hofmeister CC, Baz R, Jagannath S, Chen C, et al. (2014). Pomalidomide alone or in combination with low-dose dexamethasone in relapsed and refractory multiple myeloma: a randomized phase 2 study. Blood. (Among 221 patients with refractory multiple myeloma treated with pomalidomide with or without dexamethasone, median progression free survival was 2.6 months with pomalidomide alone and 4.6 months with addition of dexamethasone; adverse events included neutropenia, anemia, thrombocytopenia, pneumonia and fatigue; no mention of ALT elevations or hepatotoxicity).
Pauff JM, Gonzalez RS, Sajnani KP, Kassim A, Jagasia M. (2014). Post-allograft pomalidomide and reversible hepatotoxicity. Bone Marrow Transplant. (47 year old man with recurrence of multiple myeloma after hematopoietic cell transplant developed jaundice three weeks after starting pomalidomide [2 mg daily] and dexamethasone [bilirubin 16.2 mg/dL, ALT 1241 U/L, Alk P 337 U/L, protime 22.8 sec], biopsy showing marked necrosis without evidence of GvHD, liver test improving rapidly within the next 2 weeks: Case 1).
Veluswamy RR, Ward SC, Yum K, Abramovitz RB, Isola LM, Jagannath S, Parekh S. (2014). Adverse drug reaction: pomalidomide-induced liver injury. Lancet. (50 year old man with refractory, relapsed multiple myeloma and both autologous and allogeneic hematopoietic stem cell transplant developed serum ALT elevations after starting pomalidomide, which progressed to acute liver injury despite dose reduction [bilirubin 13.1 mg/dL, ALT 3981 U/L, Alk P 259 U/L] that improved on stopping and high dose prednisone but then worsened and liver biopsy suggested acute graft-vs-host disease, which responded to restarting prednisone and adding sirolimus).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to thalidomide or its derivatives).
(2015). Pomalidomide (Pomalyst) for multiple myeloma. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of pomalidomide shortly after its approval for use in the US mentions adverse side effects of neutropenia, thrombocytopenia, venous thromboses, tumor lysis syndrome, dizziness, confusion, neuropathy and acute lung toxicity; no mention of ALT elevations or hepatotoxicity).
Modi D, Mamdani H, Vettese T. (2015). Pomalidomide-Induced pulmonary toxicity in multiple myeloma. Am J Med Sci. (69 year old man with multiple myeloma developed pneumonitis [dyspnea, hypoxia, pulmonary opacities] 8 months after starting pomalidomide, resolving rapidly on stopping, recurring on reexposure, then resolving with corticosteroid therapy; no mention of liver test abnormalities).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 1 case was attributed to thalidomide, none to lenalidomide or pomalidomide).
Danhof S, Schreder M, Strifler S, Einsele H, Knop S. (2015). Long-term disease control by pomalidomide/dexamethasone-based therapy in a patient with advanced multiple myeloma: a case report and review of the literature. Case Rep Oncol. (59 year old woman with multiple myeloma underwent multiple courses of chemotherapy over a 9 year period and finally with pomalidomide, dexamethasone and doxorubicin had a partial response but developed reactivation of hepatitis B after 6 cycles [HBV DNA 10^7^ copies/mL], which was controlled by entecavir allowing for restarting therapy).
Jones JR, Pawlyn C, Davies FE, Morgan GJ. (2016). The safety of pomalidomide for the treatment of multiple myeloma. Expert Opin Drug Saf. (Review of the chemical structure, mechanism of action and safety of pomalidomide, mentions that monitoring of liver tests is recommended and that individual case reports of liver injury have been reported).
Tsukune Y, Sasaki M, Odajima T, Sunami K, Takei T, Moriuchi Y, Iino M, et al. (2017). Incidence and risk factors of hepatitis B virus reactivation in patients with multiple myeloma in an era with novel agents: a nationwide retrospective study in Japan. Blood Cancer J. (Japanese nationwide analysis of 5078 patients with multiple myeloma identified 760 with resolved hepatitis B [anti-HBc without HBsAg in serum] of whom 7.6% developed reactivation [7.9% at 2 and 14.1% at 5 years], multivariate analysis demonstrating higher rates in those undergoing autologous hematopoietic stem cell transplant [21%:odds ratio=11.6] and lower rates in those receiving lenalidomide [5.2%:odds ratio=0.5], but not thalidomide, bortezomib or dexamethasone).
Reed-Guy L, Hoteit MA, Garfall AL. (2018). Acute liver failure associated with pomalidomide therapy for multiple myeloma. Clin Lymphoma Myeloma Leuk. (56 year old man with refractory, relapsed multiple myeloma developed fever and jaundice 4 days after starting pomalidomide [bilirubin 4.6 mg/dL, ALT 907 U/L, AST 1518 U/L, LDH 1974 U/L, Alk P 92 U/L, INR 2.8, creatinine 1.9 mg/dL], with rapid improvement on stopping therapy, normal ALT and INR 2 weeks later).
Garderet L, Kuhnowski F, Berge B, Roussel M, Escoffre-Barbe M, Lafon I, Facon T, et al. (2018). Pomalidomide, cyclophosphamide, and dexamethasone for relapsed multiple myeloma. Blood. (Among 97 patients with relapsed multiple myeloma treated with pomalidomide, cyclophosphamide and dexamethasone, the objective response rate was 85% and adverse event rate [grade 3 or 4] was 70%, which were largely hematologic [62%] and infections [6%]; no hepatic events were listed).
Parisi MS, Leotta S, Romano A, Del Fabro V, Martino EA, Calafiore V, Giubbolini R, et al. (2019). Clinical benefit of long-term disease control with pomalidomide and dexamethasone in relapsed/refractory multiple myeloma patients. J Clin Med. (Among 76 patients with relapsed or refractory multiple myeloma treated with pomalidomide and dexamethasone in a Italian national program, severe [grade 3] adverse events included hematologic [51%] and non-hematologic effects [32%], which were mostly infections and none of which were hepatic).
Kikuchi T, Kusumoto S, Tanaka Y, Oshima Y, Fujinami H, Suzuki T, Totani H, et al. (2020). Hepatitis B virus reactivation in a myeloma patient with resolved infection who received daratumumab-containing salvage chemotherapy. J Clin Exp Hematop. (72 year old women with multiple myeloma who was negative for HBsAg but positive for anti-HBc without anti-HBs was monitored and had no evidence for reactivation during multiple courses of bortezomib, melphalan, dexamethasone, lenalidomide and pomalidomide over a 3 year period, but then developed HBV DNA [2.2 to 2.6 log_10_ per mL] and HBsAg after 3^rd^ course of daratumumab with bortezomib and dexamethasone with rapid response upon addition of entecavir).
Curtis LM, Ostojic A, Venzon DJ, Holtzman NG, Pirsl F, Kuzmina ZJ, Baird K, et al. (2021). A randomized phase 2 trial of pomalidomide in subjects failing prior therapy for chronic graft-versus-host disease. Blood. (Among 34 patients with moderate to severe chronic graft-vs-host disease treated with pomalidomide [0.5 or 2 mg daily], the objective response rate was 67% but all responses were partial, the most common adverse events were lymphopenia [68%], infection [47%] and fatigue [41%], and while ALT elevations above 5 times ULN arose in 6% there were cases of clinically apparent liver injury).
Terpos E, Repousis P, Lalayanni C, Hatjiharissi E, Assimakopoulou T, Vassilopoulos G, Pouli A, et al. (2021). Pomalidomide plus low-dose dexamethasone in relapsed/refractory multiple myeloma patients: results of the real-world "POWERFUL" study. J Clin Med. (Among 99 patients with relapsed or refractory multiple myeloma treated with pomalidomide and dexamethasone in a Greek National program, the response rate was 32%, and 80% of patients had at least one adverse event including 8% with hematologic and 5% with non-hematologic grade 3 events, none of which were hepatic).
Dechow T, Aldaoud A, Behlendorf T, Knauf W, Eschenburg H, Groschek M, Hansen R, et al. (2022). Pomalidomide plus dexamethasone for patients with relapsed or refractory multiple myeloma: final results of the non-interventional study POSEIDON and comparison with the pivotal phase 3 clinical trials. Eur J Haematol. (Among 144 patients with relapsed or refractory multiple myeloma treated with pomalidomide and dexamethasone in a German observational study, the overall response rate was 32% and treated related adverse events arose in 63%, which were severe [grade 3-4] in 36%, none of which were liver related).
Ramaswami R, Polizzotto MN, Lurain K, Wyvill KM, Widell A, George J, Goncalves P, et al. (2022). Safety, activity, and long-term outcomes of pomalidomide in the treatment of Kaposi sarcoma among individuals with or without HIV Infection. Clin Cancer Res. (Among 28 patients with Kaposi sarcoma [18: 65% with HIV infection] treated with pomalidomide [5 mg daily for 21 of each 28-day cycle], the objective response rate was 71% and adverse events were common including ALT elevations in 25%, all of which were transient, asymptomatic and less than 3 times ULN).

## OTHER REFERENCE LINKS

1 Recent References on Pomalidomide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pomalidomide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pomalidomide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pomalidomide)